# Phenytoin

## OVERVIEW

### Introduction

Phenytoin, formerly known as diphenylhydantoin, is a potent anticonvulsant used to treat and prevent generalized grand mal seizures, complex partial seizures and status epilepticus. Phenytoin was formerly the most commonly used anticonvulsant agent but is now declining in use, having been replaced by more modern, better tolerated agents. Phenytoin is an uncommon but well known cause of acute idiosyncratic drug induced liver disease that can be severe and even fatal.

### Background

Phenytoin (fen' i toyn) is a hydantoin derivative that has potent anti-seizure activity that is believed to be based upon stabilization of neuronal membranes caused by an increase in the efflux and decrease in the influx of sodium ions across GABA regulated sodium channels. A similar action in cardiac muscle may account for its activity against ventricular arrhythmias. Phenytoin was first approved for use in the United States in 1946, and currently more than 2 million prescriptions are filled yearly. Current indications for phenytoin are treatment and prevention of generalized tonic-clonic (grand mal) seizures and complex partial seizures and management of status epilepticus. Once the most commonly used anticonvulsant agent, phenytoin is currently less commonly used, largely because of its complex pharmacokinetics, serious adverse events and difficult drug interactions. It is also no longer used to stabilize cardiac arrhythmias not responding to lidocaine. Phenytoin is available generically in oral and parenteral formulations. Oral forms include tablets and capsules of 100 to 300 mg, including extended release formations for once daily dosing. Commercial names include Dilantin. Chewable tablets and oral suspensions are available for pediatric use. The recommended dose of phenytoin for chronic use is 300 mg daily. Common side effects include dizziness, ataxia, nausea, gum hyperplasia and rash (which can occur in 10% of patients). Phenytoin has major effects on metabolism of other medications, and patients should be provided specific advice about other medications that can be used during long term phenytoin therapy. Serious adverse events include suicidal thoughts and behaviors, agranulocytosis, aplastic anemia, severe cutaneous reactions, Stevens-Johnson syndrome, and embryo-fetal abnormalities.

### Hepatotoxicity

Prospective studies indicate that a fairly high proportion of patients taking phenytoin have transient serum aminotransferase elevations. These elevations are usually benign, not associated with liver histological abnormalities and usually resolve even with drug continuation. In addition, a higher proportion of patients have mild-to-moderate elevations in gammaglutamyl transpeptidase (GGT) levels, which is indicative of hepatic enzyme induction rather than liver injury. Marked aminotransferase elevations (>3 fold elevated) occur rarely.

Importantly, however, phenytoin is one of the most common causes of clinically apparent drug induced liver disease and acute liver failure. More than 100 cases of liver injury due to phenytoin (diphenylhydantoin) have been published and a characteristic clinical pattern (signature) of injury has been described. The estimated frequency ranges from 1 per 1000 to 1 per 10,000 and probably varies by race and ethnicity. The typical case arises after 2 to 8 weeks of therapy with initial onset of fever, rash, facial edema and lymphadenopathy, followed in a few days by jaundice and dark urine. The serum enzyme elevations can be hepatocellular, although mixed patterns are probably more common and rare cases are cholestatic. Eosinophilia, increased white counts and atypical lymphocytosis are also common. Autoantibody formation is rare. The clinical symptoms and signs can mimic acute mononucleosis or even lymphoma (pseudo-lymphoma syndrome). Almost all cases of phenytoin hepatotoxicity occur in the context of a systemic hypersensitivity syndrome and it is referred to often as the anticonvulsant hypersensitivity syndrome (HDS) or drug rash with eosinophilia and systemic symptoms syndrome (DRESS). Other manifestations can be Stevens-Johnson syndrome, toxic epidermal necrolysis, aplastic anemia, thrombocytopenia, neutropenia, nephritis, and pneumonitis. Most cases of liver injury are self-limiting and resolve within 1 to 2 months of stopping phenytoin. However, the liver injury can be severe and many fatal instances have been reported, phenytoin usually appearing in the top 10 causes of drug induced acute liver failure. In the typical case, however, recovery is usually complete.

Likelihood score: A (well known cause of clinically apparent liver injury).

### Mechanism of Injury

The liver injury caused by phenytoin appears to be due to a hypersensitivity reaction and resembles typical cases of immunoallergic hepatotoxicity. This syndrome is more common in blacks than whites, but few other risk factors have been established. In some populations, the risk of injury correlates with the presence of HLA-B*15:02. Phenytoin is metabolized by CYP 450 system to arene oxide, which may represent the toxic or immunogenic intermediate.

### Outcome and Management

Acute phenytoin hepatitis with jaundice has a fatality rate of greater than 10%. For this reason, phenytoin should be stopped promptly if symptoms of liver disease or jaundice arise early during therapy. Monitoring of ALT levels during introduction of phenytoin is recommended by some expert groups, but minor ALT elevations are common and it is unclear at what level of elevation that therapy should be suspended. Chronic injury due to phenytoin hepatotoxicity is rare or nonexistent, but cases of prolonged jaundice resembling vanishing bile duct syndrome have been reported. Rechallenge leads to rapid and usually more severe recurrence which can be fatal and should be avoided. Cross sensitivity with other aromatic anticonvulsants (phenobarbital, carbamazepine, lamotrigine and ethosuximide) can occur but is not invariable. Nevertheless, it is prudent to avoid use of these other aromatic anticonvulsants and to switch to agents such as valproate, gabapentin, levetiracetam, topiramate or a benzodiazepine, which do not appear to induce the same hypersensitivity syndrome. Corticosteroid therapy is often used in patients with severe phenytoin hepatotoxicity and anecdotal reports suggest that responses are rapid and beneficial. If used, corticosteroid therapy should be limited in dose and duration.

Drug Class: Anticonvulsants

## CASE REPORT

### Case 1. Acute immunoallergic hepatitis 3 weeks after starting phenytoin.(1)

A 25 year old man was started on phenytoin (100 mg thrice daily) for new onset seizures and developed fever, morbilliform pruritic rash and fatigue 3 weeks later. He was treated symptomatically and maintained on anticonvulsant therapy until 2 weeks later when he was admitted for worsening rash and jaundice. He had no other medical illnesses, no history of liver disease, drank little alcohol and was taking no other medications except salicylates for fever. On examination, he had a generalized erythematous rash and facial edema. His temperature was 39.5 ^o^C and he had mild cervical, axillary and inguinal adenopathy. He was jaundiced, but had no hepatomegaly or peripheral signs of liver disease. Laboratory tests showed elevations in serum enzymes and bilirubin (Table). The total white count was 18,200/μL with 13% eosinophils and 13% atypical lymphocytes. An abdominal ultrasound was normal without splenomegaly or biliary abnormalities. He tested negative for markers of hepatitis A, B and C as well as cytomegalovirus, Epstein-Barr and herpes simplex viruses. Serological tests for syphilis were negative. Phenytoin was stopped. Initially, the prothrombin time was prolonged (20.4 sec, control 11 sec), but it corrected in the following week (and after vitamin K injections). The skin rash became desquamative. A liver biopsy showed changes of acute hepatitis with some granulomata and moderate cholestasis. In follow up six weeks after onset, the rash had resolved, he was asymptomatic and all laboratory tests (white counts and liver tests) were normal.

#### Key Points

Medication: | Phenytoin (100 mg three times daily)
Pattern: | Mixed (R=4.9)
Severity: | 4+ (hospitalization for jaundice, abnormal prothrombin time)
Latency: | 3 weeks to symptoms, 5 weeks to jaundice
Recovery: | Complete within 6 weeks
Other medications: | Salicylates for fever

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Protime (sec)
5 weeks | 0 | 888 | 570 | 4.8 | 20.4
| 4 days | 1070 | 482 | 6.9 | 17.0
6 weeks | 7 days | 673 | 474 | 3.2 | 13.1
| 10 days | 247 | 316 | 2.9 | 11.0
7 weeks | 13 days | 102 | 213 | 1.6 | 12.0
11 weeks | 6 weeks | Normal | Normal | Normal
Normal Values | | <29 | <90 | <1.2

#### Comment

The patient developed a typical acute anticonvulsant hypersensitivity syndrome with fever, rash, facial edema and lymphadenopathy within 3 weeks of starting phenytoin. Signs and symptoms of hepatitis arose thereafter and phenytoin was stopped once jaundice appeared. This pattern of onset and association with immunoallergic manifestations is typical of phenytoin hepatic injury. The enzyme pattern was “mixed” hepatocellular-cholestatic pattern and the liver biopsy showed a similar pattern. The hepatic injury was severe but rapidly reversible once phenytoin was stopped, the reversal beginning ~7 days after stopping, which is typical of phenytoin hepatic injury.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Phenytoin – Generic, Dilantin®

DRUG CLASS

Anticonvulsants

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Phenytoin)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Phenytoin | 57-41-0 | C15-H12-N2-O2

## CITED REFERENCE

1 Gloria L, Serejo F, Cruz E, Freitas J, Costa A, Ramalho F, Batista A, de Moura MC. (1998). Diphenylhydantoin-induced hepatitis: a case report. Hepatogastroenterology.

## ANNOTATED BIBLIOGRAPHY

References updated: 30 July 2020

Abbreviations used: HHV, human herpes virus; DRESS, drug rash, eosinophilia and systemic signs; SJS, Stevens-Johnson syndrome; TEN, toxic epidermal necrolysis.

Zimmerman HJ. Anticonvulsants. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999: pp. 498-516. (Expert review of anticonvulsants and liver injury published in 1999 which provides a concise description of the typical signature hepatic injury associated with phenytoin).
Pirmohamed M, Leeder SJ. Anticonvulsant agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013: pp 423-442. (Review of anticonvulsant induced liver injury including phenytoin).
Smith MD, Metcalf CS, Wilcox KS. Pharmacology of the epilepsies. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 303-26. (Textbook of pharmacology and therapeutics).
Kazamatsuri H. (1970). Elevated serum alkaline phosphatase levels in epilepsy during diphenylhydantoin therapy. N Engl J Med. (Among 61 patients with epilepsy treated with phenytoin, serum Alk P levels were abnormal in 60% compared to none of 49 controls).
Pezzimenti JF, Hahn AL. (1970). Anicteric hepatitis induced by diphenylhydantoin. Arch Intern Med. (19 year old black man developed rash and fever 3 weeks after starting phenytoin with 6% eosinophils, rapid resolution, but immediate recurrence on one dose rechallenge with fever to 40 oC [eosinophils 19%, bilirubin 0.8 mg/dL, AST 226 U/L, Alk P normal, protime 18.5 sec], resolving in 3 weeks; 10 cases in the literature are reviewed, all had rash and fever, 2 fatal).
Anthony JJ. (1970). Malignant lymphoma associated with hydantoin drugs. Arch Neurol. (Review of 100 cases of hydantoin associated lymphadenopathy in the literature, most onset in 1-2 months; 4 case reports of lymphoma/leukemia after long term phenytoin therapy; no consistent pattern but suspect an increase risk of lymphatic cancer with therapy).
Andreasen PB, Lyngbye J, Trolle E. (1973). Abnormalities in liver function tests during long-term diphenylhydantoin therapy in epileptic outpatients. Acta Med Scand. (Cross sectional study of 55 “epileptics” and 250 controls for liver tests; 25% had ALT [all <3 times ULN] and 22% Alk P elevations [all <3 times ULN], mostly related to phenytoin).
Jerina DM, Daly JW. (1974). Arene oxides: a new aspect of drug metabolism. Science. (Epoxidation of aromatic double bonds yields highly reactive arene oxides which react with nucleophiles including DNA, RNA and protein; molecular basis for cytotoxicity of aromatic hydrocarbons).
Dhar GJ, Ahamed PN, Pierach CA, Howard RB. (1974). Diphenylhydantoin-induced hepatic necrosis. Postgrad Med. (20 year old woman developed fever and lymphadenopathy 15 days after starting phenytoin [2% eosinophils, AST 115 U/L, Alk P 210 U/L]; she restarted phenytoin during recovery and relapsed in 5 days [bilirubin 7.0 mg/dL, AST 113 U/L, Alk P 232 U/L], with fatal outcome; review of 17 cases in literature including 9 women, 8 men; 12 blacks; 7 died, 10 recovered).
Weedon AP. (1975). Diphenylhydantoin sensitivity. A syndrome resembling infectious mononucleosis with a morbilliform rash and cholestatic hepatitis. Aust N Z J Med. (10 year old boy developed fever, rash, sore throat and jaundice 4-5 weeks after starting phenytoin [8% eosinophils, bilirubin 11.1 mg/dL, AST 248 U/L, Alk P 625 U/L], with prolonged course of jaundice before recovery).
Kleckner HB, Yakulis V, Heller P. (1975). Severe hypersensitivity to diphenylhydantoin with circulating antibodies to the drug. Ann Intern Med. (15 year old boy developed fever and rash, followed by dark urine arising 15 days after starting phenytoin [bilirubin 3.1 mg/dL, AST 1490 U/L, Alk P 74 U/L], with progressive worsening and apparent response to prednisone; anti-BSA-phenytoin antibody of 1:320; controls negative).
Lee TJ, Carney CN, Lapis JL, Higgins T, Fallon HJ. (1976). Diphenylhydantoin-induced hepatic necrosis. A case study. Gastroenterology. (21 year old woman developed fever and lymphadenopathy 18 months after starting phenytoin and 4 weeks after starting phenobarbital [WBC 20,000, 7% eosinophils, bilirubin 18.9 mg/dL, ALT 2048 U/L, Alk P 3 times ULN], with worsening hepatic failure and death, autopsy showing massive necrosis).
Lapes MJ, Vivacqua RJ, Antoniades K. (1976). Immunoblastic lymphadenopathy associated with phenytoin (diphenylhydantoin). Lancet. (78 year old black woman developed massive diffuse lymphadenopathy on phenytoin of unmentioned duration with atypical lymphocytosis and monoclonal IgG and IgA, responding to chemotherapy; no liver tests given).
Jacobsen NO, Mosekilde L, Myhre-Jensen O, Pedersen E, Wildenhoff KE. (1976). Liver biopsies in epileptics during anticonvulsant therapy. Acta Med Scand. (Among 11 patients on long term phenytoin [10-35 years], 6 had mild ALT [37-46 U/L] and 4 Alk P elevations [282-471 U/L], but bilirubin levels were normal; all 11 had liver biopsy most showing nonspecific changes; none had fibrosis).
Charlesworth EN. (1977). Phenytoin-induced pseudolymphoma syndrome. An immunologic study. Arch Derm. (28 year old woman developed rash and lymphadenopathy 6 weeks after starting phenytoin therapy [24% eosinophils, bilirubin normal, AST 126 U/L, Alk P twice ULN], resolving rapidly on stopping; lymphocyte stimulation assays were negative).
Campbell CB, McGuffie C, Weedon AP, Powell LW. (1977). Cholestatic liver disease associated with diphenylhydantoin therapy. Possible pathogenic importance of altered bile salt metabolism. Am J Dig Dis. (10 year old boy developed rash, fever and jaundice 5 weeks after starting phenytoin [bilirubin 17.8 mg/dL, ALT ~450 U/L, Alk P above 2000 U/L], with marked and fluctuating cholestasis and high serum bile acid levels, resolving with corticosteroid therapy).
Parker WA, Shearer CA. (1979). Phenytoin hepatotoxicity: a case report and review. Neurology. (17 year old woman developed erythroderma and fever 4 weeks after starting phenytoin and phenobarbital [14% eosinophils, atypical lymphocytes, bilirubin 2.7 mg/dL, ALT 70 U/L, Alk P 210 U/L]; prednisone given but rash returned with tapering, switched to carbamazepine and phenobarbital).
Haruda F. (1979). Phenytoin hypersensitivity. Thirty-eight cases. Neurology. (Review of admissions to Johns Hopkins between 1963-77 identified 38 cases of phenytoin hypersensitivity; onset in 1-35 days, but a few for longer: rash in 74%, fever 37%, abnormal liver tests in 29%, eosinophilia in 21%).
Mullick FG, Ishak KG. (1980). Hepatic injury associated with diphenylhydantoin therapy: a clinicopathologic study of 20 cases. Am J Clin Pathol. (20 cases of phenytoin hepatotoxicity from Armed Forces Institute of Pathology files; onset of fever [75%], rash [62%], eosinophilia [89%] after 1-8 weeks of phenytoin; usually with mixed hepatocellular-cholestatic pattern of liver injury).
Aiges HW, Daum F, Olson M, Kahn E, Teichberg S. (1980). The effects of phenobarbital and diphenylhydantoin on liver function and morphology. J Pediatr. (Cross sectional study of 63 children on phenobarbital and/or phenytoin for at least 12 months found 100% had GGT elevations [mean ~twice ULN], none had 5’NT, but 17% had AST and ALT elevations; 6 on phenytoin had persistent ALT elevations [72-122 U/L] and underwent liver biopsy: slight hepatocyte swelling, but no necrosis or inflammation, electron microscopy showed proliferation of endoplasmic reticulum, over time, ALT levels fell to normal but GGT remained elevated).
Spielberg SP, Gordeon GB, Blake DA, Goldstein DA. (1981). Herlong HFl. Predisposition to phenytoin hepatotoxicity assessed in vitro. N Engl J Med. (3 women, ages 21 to 30 years, developed rash, fever and jaundice 1-4 weeks after starting phenytoin [bilirubin 7.8, 11.5 and 0.5 g/dL, AST 790, 2340 and 62 U/L, eosinophils 9%, 10% and 10%], all recovered; all had dose dependent cytotoxicity of lymphocytes exposed to microsomal metabolized [arene oxides] phenytoin).
Cook IF, Shilkin KB, Reed WD. (1981). Phenytoin induced granulomatous hepatitis. Aust N Z J Med. (15 year old girl developed rash 10 days after starting carbamazepine; later started phenytoin and developed rash and fever after 6 weeks [bilirubin 2.4 mg/dL, AST 212 U/L, Alk P 639 U/L, 8% eosinophils], biopsy showed granulomas and hepatitis).
Spechler SJ, Sperber H, Doos WG, Koff RS. (1981). Cholestasis and toxic epidermal necrolysis associated with phenytoin sodium ingestion: the role of bile duct injury. Ann Intern Med. (29 year old developed severe rash and jaundice 2 weeks after starting phenytoin [bilirubin 7.8 rising to 37.5 mg/dL, ALT 147 U/L, Alk P 201 rising to 2710 U/L], with prolonged cholestasis and recovery only after 8 months; liver biopsy showed intrahepatic cholestasis).
Cacatian AA, Rando J. (1981). Diphenylhydantoin-induced pseudolymphoma syndrome. With severe thrombocytopenia. N Y State J Med. (43 year old woman on phenytoin for ~20 years developed thrombocytopenia requiring splenectomy; unclear why case was considered pseudo-lymphoma or whether it was due to phenytoin, no fever or rash and minimal lymphadenopathy).
Ting S, Dunsky EH. (1982). Diphenylhydantoin-induced hepatitis. Ann Allergy. (17 year old black male developed rash, fever and lymphadenopathy 2 weeks after starting phenytoin [bilirubin 3.2 mg/dL, ALT 780 U/L, Alk P 140 U/L, 18% eosinophils], treated with prednisone with rapid response; rechallenge led to rash in 6 hours but rapid recovery; had a positive lymphocyte stimulation test to phenytoin).
Rosenthal CJ, Noguera CA, Coppola A, Kapelner SN. (1982). Pseudolymphoma with mycosis fungoides manifestations, hyperresponsiveness to diphenylhydantoin, and lymphocyte disregulation. Cancer. (2 men and 1 woman, ages 18 to 47 years, developed severe exfoliative dermatitis, fever, lymphadenopathy and hepatomegaly at unspecified times after starting phenytoin [bilirubin not mentioned, ALT 72-430 U/L, Alk P 115-830 U/L, 13-23% eosinophilia], with Sezary cells and skin biopsy findings suggestive of mycosis fungoides, but which resolved when phenytoin was stopped).
Tomsick RS. (1983). The phenytoin syndrome. Cutis. (Five case reports of African-Americans with onset after 1 to 4 weeks of phenytoin therapy of rash [erythroderma, morbilliform, toxic epidermal necrolysis [TEN], follicular papules and pustules], fever, eosinophilia [13-40%], and ALT abnormalities [37-1211 U/L]; 2 had jaundice, 2 died due to relapsing TEN and sepsis, 3 recovered within 2-4 weeks).
Perucca E, Hedges A, Makki KA, Ruprah M, Wilson JF, Richens A. (1984). A comparative study on the relative enzyme inducing properties of anticonvulsant drugs in epileptic patients. Br J Clin Pharmacol. (Cross sectional study of antipyrine clearance in 122 patients with epilepsy, found dose dependent increase in clearance in those on phenytoin, phenobarbital and carbamazepine, but not on valproate).
Taylor JW, Stein MN, Murphy MJ, Mitros FA. (1984). Cholestatic liver dysfunction after long-term phenytoin therapy. Arch Neurol. (64 year old woman treated with phenytoin for 41 years developed anorexia and jaundice with ascites [bilirubin 7.9 mg/dL, AST 74 U/L, Alk P 167 U/L], with biopsy showing intrahepatic cholestasis; rapid recovery but recurrence on restarting phenytoin [bilirubin 1.5 mg/dL, AST 450 U/L, Alk P 251 U/L]; no recurrence on switching to carbamazepine and mephobarbital).
Kahn HD, Faguet GB, Agee JF, Middleton HM. (1984). Drug-induced liver injury. In vitro demonstration of hypersensitivity to both phenytoin and phenobarbital. Arch Intern Med. (16 year old girl developed fever, facial edema, lymphadenopathy and rash 3 weeks after starting phenobarbital and phenytoin [bilirubin 0.3 mg/dL, AST 62 U/L, Alk P 123 U/L]; stopping phenytoin had no effect, but she improved with stopping phenobarbital and had positive lymphocyte stimulation tests to both drugs).
Aaron JS, Bank S, Ackert G. (1985). Diphenylhydantoin-induced hepatotoxicity. Am J Gastroenterol. (64 year old black man developed rash and fever 3 weeks after starting phenytoin and was switched to phenobarbital, but 1 week later developed jaundice [bilirubin 3.4 mg/dL, ALT 456 U/L, Alk P 557 U/L, 19% eosinophils, 8% atypical lymphocytes], which worsened for a week, but ultimately resolved completely).
Wolf R, Kahane E, Sandbank M. (1985). Mycosis fungoides-like lesions associated with phenytoin therapy. Arch Derm. (78 year old lady developed 2 small mycosis fungoides like plaques on the skin and lymphadenopathy 11 months after starting phenytoin [6% eosinophils, but normal AST, Alk P and bilirubin], plaques remained for next 2 years while on phenytoin when biopsy showed mycosis fungoides; stopping phenytoin and switching to carbamazepine was followed by resolution of skin lesions and lymphadenopathy).
Ratnaike RN, Schapel GJ, Purdie G, Rischbieth RH, Hoffmann S. (1986). Hyperammonaemia and hepatotoxicity during chronic valproate therapy: enhancement by combination with other antiepileptic drugs. Br J Clin Pharmacol. (Cross sectional analysis of ammonia levels and liver tests in 81 patients with epilepsy; higher average levels of ammonia in patients on valproate [37.1 vs 28.7 μmol], slightly higher rate of elevations in those receiving other agents [phenytoin, carbamazepine] as well).
Riera Velasco JR, Rodrigo Saez LR, Perez Alvarez M, Gonzalez G. (1986). Hepatitis cronica activa por difenilhidantoinas. Med Clin (Barc). (49 year old man with a history of alcoholism developed evidence of liver disease, 2 years after starting phenytoin [bilirubin 0.4 mg/dL, ALT 113 U/L, Alk P 115 U/L], biopsy showing chronic hepatitis and ground-glass hepatocytes; likely chronic hepatitis C and cell-ER-activation by phenytoin rather than hepatotoxicity; only mild improvement upon stopping drug; report predates tests for anti-HCV).
Brown M, Schubert T. (1986). Phenytoin hypersensitivity hepatitis and mononucleosis syndrome. J Clin Gastroenterol. (23 year old black woman with seizures developed fever, sore throat, rash and lymphadenopathy 5 weeks after starting phenytoin and 3 weeks after starting carbamazepine; drugs were stopped, and she was given iv phenytoin for a seizure, immediately redeveloping fever, severe exfoliative rash, facial edema and jaundice [bilirubin 5.6 mg/dL, ALT 1530 U/L, Alk P 267 U/L, protime 20.4 sec], responding slowly to corticosteroids: thorough review of rechallenge studies).
Engel JN, Mellul VG, Goodman DBP. (1986). Phenytoin hypersensitivity: a case of severe acute rhabdomyolysis. Am J Med. (22 year old black man developed fever, rash, myalgias and facial edema 3 months after starting phenytoin [normal bilirubin ALT 90 U/L, AST 510 U/L, CPK 85,000 U/L, 9% eosinophils], responding to stopping drug and prednisone therapy).
Deutsch J, Fritsch G, Golles J, Semmelrock HJ. (1986). Effects of anticonvulsive drugs on the activity of gammaglutamyltransferase and aminotransferases in serum. J Pediatr Gastroenterol Nutr. (Cross sectional study of 198 children on anticonvulsants; GGT levels were usually high and correlated with phenytoin levels, less with other agents; provided mean levels and not proportion with abnormalities).
Sherertz EF, Jegasothy BV, Lazarus GS. (1985). Phenytoin hypersensitivity reaction presenting with toxic epidermal necrolysis and severe hepatitis. Report of a patient treated with corticosteroid “pulse therapy”. J Am Acad Dermatol. (49 year old black man developed fever and lymphadenopathy 3 weeks after starting phenytoin [bilirubin 2.5 mg/dL, AST 246 U/L, Alk P 168 U/L]; rechallenge with a single dose led to a recurrence with near fatal outcome, use of high dose corticosteroids was complicated by perforation of a duodenal ulcer).
Keeffe EB, Sunderland MC, Gabourel JD. (1986). Serum gamma-glutamyltranspeptidase activity in patients receiving chronic phenytoin therapy. Dig Dis Sci. (Among 58 patients started on phenytoin, GGT levels increased in 90%; levels were abnormal in 22% at baseline and in 74%, 63% and 64% at 6, 12 and 24 months, levels rising from mean of 45 to 136 U/L at 6 months, peak levels 400-500 U/L, higher in patients who drank alcohol and higher in patients than controls).
Shear NH, Spielberg SP. (1988). Anticonvulsant hypersensitivity syndrome: in vitro assessment of risk. J Clin Invest. (Peripheral blood mononuclear cells cytotoxicity in response to drug metabolites from 53 patients with hypersensitivity to anticonvulsants including 35/36 to phenytoin, 22/27 to phenobarbital, and 25/27 to carbamazepine; 51% had hepatitis).
Silverman AK, Fairley J, Wong RC. (1988). Cutaneous and immunologic reactions to phenytoin. J Am Acad Dermatol. (Extensive review of dermatologic complications of phenytoin therapy, including acne, exfoliative dermatitis, erythema multiforme, hyperpigmentation, maculopapular rashes, pseudolymphoma, toxic epidermal necrolysis, vasculitis, bullous reactions, gingival hyperplasia and coarsening of facial features).
Aldenhövel HG. (1988). The influence of long-term anticonvulsant therapy with diphenylhydantoin and carbamazepine on serum gamma-glutamyltransferase, aspartate aminotransferase, alanine aminotransferase and alkaline phosphatase. Eur Arch Psychiatry Neurol Sci. (Serum enzymes done on 54 patients on phenytoin and 56 on carbamazepine; GGT elevations [14-283 U/L] in 91% vs 64%, ALT [5-48 U/L] in 28% vs 9%, and Alk P [14 to 218 U/L] in 39% vs 14%, most elevations were modest; GGT elevations were dose related, but not the others).
Roberts EA, Spielberg SP, Goldbach M, Phillips MJ. (1990). Phenobarbital hepatotoxicity in an 8-month-old infant. J Hepatol. (8 month old male child with seizures given phenobarbital for 2 weeks developed rash followed by fever with eosinophilia, atypical lymphocytes, ALT 430 U/L, Alk P 135 U/L, bilirubin 2.9 mg/dL, slow recovery, positive lymphocyte cytotoxicity test to phenobarbital, phenytoin and carbamazepine).
Howard PA, Engen PL, Dunn MI. (1991). Phenytoin hypersensitivity syndrome: a case report. DICP. (27 year old black man developed rash 2 weeks and fatigue and fever 4 weeks after starting phenytoin [bilirubin 1.2 rising to 5.7 mg/dL, ALT 1050 U/L, Alk P 239 U/L, 15% eosinophils, 11% atypical lymphocytes], with subsequent severe course, but improvements starting 5 days after stopping phenytoin and ultimate full recovery).
Kleier RS, Breneman DL, Boiko S. (1991). Generalized pustulation as a manifestation of the anticonvulsant hypersensitivity syndrome. Arch Dermatol. (2 men, ages 21 and 49 years, developed rash after 3-4 weeks of phenytoin evolving into sterile pustules; eosinophilia and fever [bilirubin normal, ALT 57 and 660 U/L, Alk P 85 and 117 U/]L, worsening on switching to carbamazepine and phenobarbital, resolving after switching to clonazepam).
Gennis MA, Vemuri R, Burns EA, Hill JV, Miller MA, Spielberg SP. (1991). Familial occurrence of hypersensitivity to phenytoin. Am J Med. (3 siblings, ages 23 to 32 years, developed fever, rash, facial edema, lymphadenopathy, eosinophilia and anicteric hepatitis 2-21 days after starting phenytoin, resolving rapidly; index case had in vitro evidence of toxicity of carbamazepine and phenytoin, but not phenobarbital and similar findings in siblings).
Roy AK, Mahoney HC, Levine RA. (1993). Phenytoin-induced chronic hepatitis. Dig Dis Sci. (52 year old woman had chronic, mild ALT elevations on long term phenytoin [bilirubin and Alk P normal], biopsy showing mild inflammation without fibrosis, ALT elevations resolved rapidly with stopping and recurred within 5 days of rechallenge).
Handfield-Jones SE, Jenkins RE, Whittaker SJ, Besse CP, McGibbon DH. (1993). The anticonvulsant hypersensitivity syndrome. Br J Dermatol. (2 women and 1 man, ages 20, 46 and 61 years developed fever and rash 3, 4 and 10 weeks after starting phenytoin or carbamazepine; two required corticosteroids; only 1 had hepatitis; one died of multiorgan failure, others switched to valproate or clobazam without recurrence).
García-Samaniego J, Soriano V, Soto J, Muñoz F. (1994). An Med Interna. (15 year old developed fever and oral ulcers 2 months after starting phenytoin, followed by rash, pruritus and adenopathy [bilirubin 8 mg/dL, ALT 780 U/L, Alk P 836 U/L and eosinophilia]; given corticosteroids and switched to valproate and recovered).
Vittorio CC, Muglia JJ. (1995). Anticonvulsant hypersensitivity syndrome. Arch Intern Med. (One 24 year old woman and a 38 year old man developed anticonvulsant hypersensitivity syndrome, 4 and 6 weeks after starting carbamazepine [bilirubin 0.6 and 4.1 mg/dL, ALT 402 and 1890 U/L, Alk P 184 and 487 U/L], both recovered but required corticosteroid therapy).
Mauri-Hellweg D, Bettens F, Mauri D, Brander C, Hunziker T, Pichler WJ. (1995). Activation of drug-specific CD4+ and CD8+ T cells in individuals allergic to sulfonamides, phenytoin, and carbamazepine. J Immunol. (In vitro lymphocyte studies on patients with drug allergy, found proliferation in response to specific drugs, including phenytoin, with proliferation of both CD4 and CD8 T cells and increase in CD-25 and HLA-DR expression and production of IL5 and IFNγ).
de la Serna Higuera C, Gil Grande LA, Barcena Marugan R. (1995). Gastroenterol Hepatol. (51 year old woman developed rash, fever and then jaundice 3 weeks after starting phenytoin [bilirubin 8.2 mg/dL, ALT 847 U/L, Alk P 1782 U/L, 15% eosinophilia], and slow biochemical recovery).
Schneider S, Charles F, Chichmanian RM, Montoya ML, Rampal P. (1995). Gastroenterol Clin Biol. (37 year old woman developed right upper quadrant pain after 6 months of Atrium therapy [bilirubin rising to 2.0 mg/dL, ALT 9 times ULN, Alk P normal, ANA 1:1000], biopsy showed microvesicular fat; also on carbimazole and phenytoin).
Wallace SJ. (1996). A comparative review of the adverse effects of anticonvulsants in children with epilepsy. Drug Saf. (Systematic review; ALT elevations occur in 4% of children on phenytoin, 6% on valproate, 1% on carbamazepine, but not with gabapentin or phenobarbital; skin rash and Stevens-Johnson syndrome discussed related to phenobarbital).
Chopra S, Levell NJ, Cowley G, Gilkes JJH. (1996). Systemic corticosteroids in the phenytoin hypersensitivity syndrome. Br J Dermatol. (46 year old woman developed rash and fever, 8 weeks after starting phenytoin [bilirubin 1.0 mg/dL, AST 96 U/L, Alk P 642 U/L, 7% eosinophils], with rapid response to prednisone, relapse when stopped early).
Conger LA, Grabski WJ. (1996). Dilantin hypersensitivity reaction. Cutis. (41 year old woman developed fever, rash, lymphadenopathy and facial edema 6 weeks after starting phenytoin [no mention of bilirubin, ALT 63 U/L, Alk P 137 U/L, 13% eosinophils, 3% atypical lymphocytes], resolving rapidly upon stopping).
Schlienger RG, Shear NH. (1998). Antiepileptic drug hypersensitivity syndrome. Epilepsia. (Review: onset 2-8 weeks after starting therapy with aromatic anticonvulsants presenting with high fever, rash, adenopathy and pharyngitis followed by organ involvement, most commonly the liver [~50%], but also hematologic, renal or pulmonary; eosinophilia, blood dyscrasias, nephritis; sometimes facial edema, oral ulcers, hepatosplenomegaly, myopathy, disseminated intravascular coagulation, atypical lymphocytosis; rash usually exanthema with pruritus, occasional follicular pustules or exfoliative dermatitis and erythroderma, erythema multiforme, Stevens-Johnson syndrome or toxic epidermal necrolysis).
Gloria L, Serejo F, Cruz E, Freitas J, Costa A, Ramalho F, Batista A, Carneiro de Moura M. (1998). Diphenylhydantoin-induced hepatitis: a case report. Hepatogastroenterology. (25 year old man developed fever, rash, facial edema and malaise 3 weeks after starting phenytoin followed by jaundice [bilirubin 6.9 mg/dL, ALT 888 U/L, Alk P 570 U/L, 13% eosinophils], resolving within 6 weeks of stopping).
Knowles SR, Shapiro LE, Shear NH. (1999). Anticonvulsant hypersensitivity syndrome: incidence, prevention and management. Drug Saf. (Classic review of anticonvulsant hypersensitivity syndrome: triad of fever, rash and internal organ injury occurring 1-8 weeks after exposure to anticonvulsant, liver being most common internal organ involved. Occurs in 1:1000-1:10,000 initial exposures to phenytoin, carbamazepine, phenobarbital or lamotrigine, unrelated to dose, perhaps predisposed by valproate; liver injury arises 1-4 weeks after onset of rash and ranges in severity from asymptomatic ALT elevations to icteric hepatitis to acute liver failure. High mortality rate with jaundice; other organs include muscle, kidney, brain, heart and lung. Pseudolymphoma syndrome and serum sickness like syndrome are separate complications of anticonvulsants. Role of corticosteroids uncertain; cross reactivity among the agents should be assumed).
Kakar A, Byotra SP. (1999). Phenytoin induced severe agranulocytosis and hepatitis. J Assoc Physicians India. (45 year old woman developed fever one week after starting phenytoin [bilirubin not given, ALT 106 U/L, Alk P 913 U/L]).
Hamer HM, Morris HH. (1999). Hypersensitivity syndrome to antiepileptic drugs: a review including new anticonvulsants. Cleve Clin J Med. (Clinical review of anticonvulsant hypersensitivity syndrome; occurs in 1-5/10,000 users, higher risk in African Americans and siblings of affected subjects; liver involvement common, but most cases anicteric; other manifestations are facial edema, lymphadenopathy, bone marrow aplasia, pseudolymphoma, thyroiditis, pneumonitis and interstitial nephritis).
Hamer HM, Morris HH. (1999). Successful treatment with gabapentin in the presence of hypersensitivity syndrome to phenytoin and carbamazepine: a report of three cases. Seizure. (3 patients with onset of rash, fever, lymphadenopathy and eosinophilia 4-6 weeks after starting either phenytoin or carbamazepine, [bilirubin 0.5-1.8 mg/dL, ALT 866-1402 U/L, Alk P 69-364U/L], all 3 later tolerated gabapentin).
Nashed MH, Liao L. (2001). Possible atypical cross-sensitivity between phenytoin and carbamazepine in the anticonvulsant hypersensitivity syndrome. Pharmacotherapy. (73 year old black woman developed rash, fever and confusion 3-4 weeks after starting phenytoin and failed to improve when switched to carbamazepine [peak bilirubin 0.7 mg/dL, ALT 77 U/L, Alk P 521, 19% eosinophils], with rapid resolution on stopping both).
Güngör E, Alli N, Comoğlu S, Cömcüoğlu C. (2001). Phenytoin hypersensitivity syndrome. Neurol Sci. (5 cases from Turkey, with fever, rash, edema, eosinophils and increased white blood cell counts, 2 days to 3 months after starting phenytoin [bilirubin normal, ALT 34-97 U/L, Alk P 498-747 U/L], rapid recovery after stopping).
Bessmertny O, Hatton RC, Gonzalez-Peralta RP. (2001). Antiepileptic hypersensitivity syndrome in children. Ann Pharmacother. (Among 14 children with anticonvulsant hypersensitivity syndrome, 58% were receiving phenytoin, 43% carbamazepine, and 29% phenobarbital; 63% had ALT and 36% bilirubin elevations and 1 died of hepatic failure).
Kaur S, Sarkar R, Thami GP, Kanwar AJ. (2002). Anticonvulsant hypersensitivity syndrome. Pediatr Dermatol. (13 year old boy on phenytoin developed fever, rash and facial edema 1 month after starting carbamazepine [bilirubin 0.4 mg/dL, ALT 72 U/L, Alk P 551 U/L] and did not improve until both agents were stopped, subsequently remaining well on valproate).
Galindo PA, Borja J, Gómez E, Mur P, Gudín M, García R, Encinas C, et al. (2002). Anticonvulsant drug hypersensitivity. J Investig Allergol Clin Immunol. (Patch testing on 15 patients with skin reactions to anticonvulsants; 12 were positive, often to several of the aromatic anticonvulsants).
Altuntaş Y, Oztürk B, Erdem L, Günes G, Karul S, Uçak S, Sengül A. (2003). Phenytoin-induced toxic cholestatic hepatitis in a patient with skin lesions: case report. South Med J. (47 year old woman developed exfoliative rash 25 days after starting phenytoin with fever, leukocytosis, eosinophilia and hepatitis [bilirubin 6.4 mg/dL, ALT 441 U/L, Alk P 1431 U/L], rapid improvement on stopping).
Choi TS, Doh KS, Kim SH, Jang MS, Suh KS, Kim ST. (2003). Clinicopathological and genotypic aspects of anticonvulsant-induced pseudolymphoma syndrome. Br J Dermatol. (8 patients from Korea with maculopapular rash, fever, lymphadenopathy and facial edema arising 3 to 24 [mean=7] weeks after starting an anticonvulsant, elevated liver tests in 5; largely dermatologic description).
Russo MW, Galanko JA, Shrestha R, Fried MW, Watkins P. (2004). Liver transplantation for acute liver failure from drug induced liver injury in the United States. Liver Transpl. (Among ~50,000 liver transplants done in the United States between 1990 and 2002, 137 [0.2%] were done for idiosyncratic drug induced acute liver failure, of which 10 were attributed to phenytoin, 10 to valproate and 1 to carbamazepine, but none to lamotrigine or other anticonvulsants).
Björnsson E, Jerlstad P, Bergqvist A, Olsson R. (2005). Fulminant drug-induced hepatic failure leading to death or liver transplantation in Sweden. Scand J Gastroenterol. (36 years of reporting to Swedish registry identified 103 cases of acute liver failure due to drugs, of which 1 was attributed to phenytoin, 1 to valproate and 1 to carbamazepine, but none to lamotrigine or other anticonvulsants ).
Sierra NM, García B, Marco J, Plaza S, Hidalgo F, Bermejo T. (2005). Cross hypersensitivity syndrome between phenytoin and carbamazepine. Pharm World Sci. (Among 20 patients with anticonvulsant hypersensitivity syndrome due to carbamazepine or phenytoin who were restarted on the other opposite agent, 9 redeveloped hypersensitivity features, but 8 were subsequently able to tolerate valproate [4], vigabatrin [2] or phenobarbital [2] without problems).
Björnsson E, Olsson R. (2006). Suspected drug-induced liver fatalities reported to the WHO database. Dig Liver Dis. (In WHO database of fatal adverse drug reactions from 1968-2003 including 4690 reports of drug induced liver fatality, phenytoin ranked 12th [57 cases], the only anticonvulsant among the top 19 causes).
Korem M, Hiller N, Ackerman Z, Chajek-Shaul T, Abramowitz Y. (2006). Spleen rupture secondary to anticonvulsant hypersensitivity syndrome. Eur J Intern Med. (23 year old woman developed rash, fever, edema and eosinophilia [27%] 2 months after starting phenytoin [Alk P 320 U/L, but no bilirubin or ALT values], suffered spontaneous splenic rupture, but was managed medically).
Tohyama M, Hashimoto K, Yasukawa M, Kimura H, Horikawa T, Nakajima K, Urano Y, et al. (2007). Association of human herpes virus 6 reactivation with the flaring and severity of drug-induced hypersensitivity syndrome. Br J Dermatol. (Anti-HHV-6 testing of 100 patients with drug induced hypersensitivity syndrome [34% with hepatitis] found rise in IgG levels in 62 patients, largely in more severe cases; human herpes virus [HHV]-6 DNA detected in 18; drugs included carbamazepine, phenobarbital, phenytoin, allopurinol, sulfasalazine and mexiletine).
Mansur AT, Pekcan Yaşar S, Göktay F. (2008). Anticonvulsant hypersensitivity syndrome: clinical and laboratory features. Int J Dermatol. (Among 31 patients seen at a single Turkish medical center with anticonvulsant hypersensitivity syndrome, 48% had received carbamazepine, 36% phenytoin, 10 lamotrigine and 6% lamotrigine and valproate; onset 2-86 days after starting with ALT elevations in 71%, eosinophilia in 64%, only one death [TEN]).
Björnsson E. (2008). Hepatotoxicity associated with antiepileptic drugs. Acta Neurol Scand. (Review of all anticonvulsants; phenytoin usually causes liver injury as a part of the hypersensitivity syndrome, in 1:10,000 to 1:50,000 persons, 100 published cases, mean onset at 4 weeks, 13% mortality).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J, Drug Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, valproate accounted for 6 cases, lamotrigine 5, phenytoin 5, gabapentin and topiramate 1 each).
Ito S, Shioda M, Sasaki K, Imai K, Oguni H, Osawa M. (2009). Agranulocytosis following phenytoin-induced hypersensitivity syndrome. Brain Dev. (5 year old boy with hypersensitivity syndrome after 12 days of phenytoin with mild ALT elevations [154 U/L] but no jaundice, who suffered from transient neutropenia during recovery).
Crespo Pérez L, Moreira Vicente V, Cano Ruiz A, Gobernado Serrano JM, Cobo Ibañez N, Milicua Salamero JM. (2009). Gastroenterol Hepatol. (15 year old girl developed fever, rash and adenopathy 6 weeks after starting carbamazepine and phenytoin [peak bilirubin 16.3 mg/dL, ALT 809 U/L, GGT 809 U/L, eosinophils 5%], resolving within a month of stopping both drugs).
Franciotta D, Kwan P, Perucca E. (2009). Genetic basis for idiosyncratic reactions to antiepileptic drugs. Curr Opin Neurol. (Review of the genetic associations with hypersensitivity reactions to anticonvulsant medications; closest association has been with HLA-B*15:02 and Stevens-Johnson syndrome [SJS] after aromatic anticonvulsants).
Newell BD, Moinfar M, Mancini AJ, Nopper AJ. (2009). Retrospective analysis of 32 pediatric patients with anticonvulsant hypersensitivity syndrome (ACHSS). Pediatr Dermatol. (Among 32 children with anticonvulsant hypersensitivity syndrome seen at two medical centers, 12 had been exposed to phenytoin, 13 carbamazepine, 5 phenobarbital, 5 lamotrigine and 1 primidone [who also received lamotrigine]; liver involved in 91%, but jaundice in just 18%, no deaths).
Devarbhavi H, Dierkhising R, Kremers WK, Sandeep MS, Karanth D, Adarsh CK. (2010). Single-center experience with drug-induced liver injury from India: causes, outcome, prognosis, and predictors of mortality. Am J Gastroenterol. (313 cases of drug induced liver injury were seen over a 12 year period at a large hospital in Bangalore, India; 21 [6.7%] were attributed to phenytoin, one of which was fatal).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury including 8 due to phenytoin, 3 to carbamazepine and 2 to valproate).
Ferrajolo C, Capuano A, Verhamme KM, Schuemie M, Rossi F, Stricker BH, Sturkenboom MC. (2010). Drug-induced hepatic injury in children: a case/non-case study of suspected adverse drug reactions in VigiBase. Br J Clin Pharmacol. (Worldwide pharmacovigilance database contained 9036 hepatic adverse drug reactions in children, phenytoin accounting for 57 cases [0.6%, ranking 20th] for an adjusted relative risk odds ratio of 3.0).
Devarbhavi H, Karanth D, Prasanna KS, Adarsh CK, Patil M. (2011). Drug-Induced liver injury with hypersensitivity features has a better outcome: a single-center experience of 39 children and adolescents. Hepatology. (Among 39 children with drug induced liver disease seen at a single referral center in India between 2005 and 2010, 10 cases were due to phenytoin and 6 to carbamazepine, all of whom survived in contrast to deaths of 12 of 23 children with hepatocellular injury without signs of hypersensitivity [largely due antituberculosis medications]).
Molleston JP, Fontana RJ, Lopez MJ, Kleiner DE, Gu J, Chalasani N, Drug-Induced Liver Injury Network. (2011). Characteristics of idiosyncratic drug-induced liver injury in children: results from the DILIN Prospective Study. J Pediatr Gastroenterol Nutr. (Among 30 children with drug induced liver injury enrolled in a prospective US database between 2004 and 2008, 8 were due to anticonvulsants [lamotrigine in 3, valproate in 3, phenytoin in 1 and carbamazepine in 1], none of which were fatal or led to chronic injury).
Neuman MG, Cohen L, Nanau RM, Hwang PA. (2012). Genetic and immune predictors for hypersensitivity syndrome to antiepileptic drugs. Transl Res. (Study of 20 patients with hypersensitivity reactions to phenytoin or carbamazepine and 40 controls found positive lymphocyte toxicity assays in all patients with hypersensitivity and a correlation of HLA-B*15:02 with the allergic reactions in Han Chinese).
Knowles SR, Dewhurst N, Shear NH. (2012). Anticonvulsant hypersensitivity syndrome: an update. Expert Opin Drug Saf. (Updated review of anticonvulsant hypersensitivity syndrome; associated with phenytoin, phenobarbital, lamotrigine and carbamazepine and rarely with zonisamide, valproate and oxcarbazepine).
(2013). Drugs for epilepsy. Treat Guidel Med Lett. (Concise review of indications and side effects of anticonvulsants mentions that phenytoin is no longer considered a drug of first choice because of its pharmacokinetics, side effects and drug-drug interactions, and that phenytoin can cause hypersensitivity reactions, Stevens-Johnson syndrome and fatal hepatitis).
Gaeti WP, Obreli-Neto PR, Moliterno RA, Schiavon GB, Cuman RK. (2013). HLA typing in Brazilian boys with aromatic antiepileptic drug-induced DRESS. Int J Clin Pharm. (9 and 11 year old boys developed rash, fever, facial edema and eosinophilia [8-14%] 27 and 19 days after starting an anticonvulsant [carbamazepine and phenytoin], with elevations in ALT [631 and 222 U/L] and Alk P [835 and 439 U/L] without jaundice; HLA testing showed no commonality and absence of B*15:02]).
Ghabril M, Fontana R, Rockey D, Jiezhun G, Chalasani N. (2013). Drug-induced liver injury caused by intravenously administered medications: The Drug-induced Liver Injury Network experience. J Clin Gastroenterol. (Among 524 cases of drug induced liver injury from the US, 32 were attributed to intravenous medications including 3 to phenytoin).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. (2013). Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, including 1 attributed to phenytoin among only 410 persons receiving the drug in Iceland).
Keel BR, Payne CL. (2013). Anticonvulsant hypersensitivity syndrome (AHS): a case report. Tenn Med. (40 year old African-American woman developed a desquamating rash, fever and abdominal pain 3-4 weeks after starting phenytoin [bilirubin 0.3 mg/dL, ALT 245 rising to 690 U/L, Alk P 88, INR 1.2], which began to resolve 5 days after stopping).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A, Chirino R, et al. (2014). Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, 7 [4%] of which were attributed to anticonvulsants including 3 due to phenytoin, 2 of which were fatal).
Velasco MJ, McDermott J. (2014). Drug rash with eosinophilia and systemic symptoms (DRESS) syndrome and hepatitis induced by phenytoin. Int J Dermatol. (33 year old man developed fever, rash, and eosinophilia 23 days after starting phenytoin for seizures [bilirubin 2.5 rising to 11.7 mg/dL, ALT 501 to 1703 U/L, Alk P 255 U/L] treated with corticosteroids with slow recovery).
Devarbhavi H, Andrade RJ. (2014). Drug-induced liver injury due to antimicrobials, central nervous system agents, and nonsteroidal anti-inflammatory drugs. Semin Liver Dis. (Review of drug induced liver injury caused by several drug classes including antiepileptics, which account for 2-11% of all cases in various registries; a common presentation is with DRESS, particularly with the older agents such as carbamazepine, phenytoin and phenobarbital and often associated with reactivation of human herpes virus 6 or 7).
Rolls S, Hyams C, Sheaff M, O'Shaughnessy TC. (2015). Is this still just sarcoidosis, or should we a-DRESS a different diagnosis?. BMJ Case Rep. (48 year old Afro-Caribbean woman with rheumatoid arthritis developed fevers and pneumonitis after starting therapy with methotrexate and sulfasalazine and then severe toxic epidermal necrolysis after starting phenytoin for seizures during her hospitalization, slowly responding to corticosteroid therapy).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 40 [4.5%] were due to anticonvulsants including 12 due to phenytoin, 9 lamotrigine, 7 valproate, 4 carbamazepine, 3 gabapentin, 2 topiramate and 1 each for ethosuximide, fosphenytoin, and pregabalin).
Trivedi BS, Darji NH, Malhotra SD, Patel PR. (2016). Antiepileptic drugs-induced Stevens-Johnson syndrome: a case series. J Basic Clin Pharm. (Among 9 cases of Stevens-Johnson syndrome seen at a large referral center in India, 5 were due to phenytoin, 2 carbamazepine and 2 oxcarbazepine; no mention of hepatic involvement).
Chalasani N, Reddy KRK, Fontana RJ, Barnhart H, Gu J, Hayashi PH, Ahmad J, Stolz A, Navarro V, Hoofnagle JH. (2017). Idiosyncratic drug induced liver injury in African-Americans is associated with greater morbidity and mortality compared to Caucasians. Am J Gastroenterol. (Among subjects enrolled in a US prospective database of drug induced liver injury, causes more frequent in African Americans than Caucasians were trimethoprim/sulfamethoxazole, methyldopa, phenytoin and allopurinol; in addition, African Americans were more likely to have severe skin adverse events [2.1% vs 0.4%], fatal or transplantation outcomes [10% vs 6%] as well as chronic injury [24% vs 16%]).
Vidaurre J, Gedela S, Yarosz S. (2017). Antiepileptic drugs and liver disease. Pediatr Neurol. (Review of the use of anticonvulsants in patients with liver disease recommends use of agents that have little hepatic metabolism such as levetiracetam, lacosamide, topiramate, gabapentin and pregabalin, levetiracetam being an "ideal" first line therapy for patients with liver disease because of its safety and lack of pharmacokinetic interactions).
(2017). Drugs for epilepsy. Med Lett Drugs Ther. (Concise review of the drugs available for therapy of epilepsy lists phenytoin as effective for partial and generalized but no longer the drug of choice because of its complicated pharmacokinetics, adverse events and drug interactions; among side effects, rash, fever, hepatotoxicity and Stevens-Johnson syndrome are mentioned).
Curry B, Mican L, Smith TL. (2018). Phenytoin-induced chronic liver enzyme elevation and hepatic fibrosis: A case report. Ment Health Clin. (50 year old African American female developed mild elevations in serum enzymes while on phenytoin [ALT rising from 11 to 139 U/L and Alk P from 40 to 180 U/L], persisting for several years and not decreasing with stopping valproate and atorvastatin but promptly falling into the normal range when phenytoin was stopped; presence of fibrosis was suggested by abdominal ultrasound but liver biopsy was not done).
Borrelli EP, Lee EY, Descoteaux AM, Kogut SJ, Caffrey AR. (2018). Stevens-Johnson syndrome and toxic epidermal necrolysis with antiepileptic drugs: An analysis of the US Food and Drug Administration Adverse Event Reporting System. Epilepsia. (Review of adverse event reports to the FDA between 2014 and 2018 identified ~2.9 million reports, 1034 for SJS/TEN, the most common class of drugs being anticonvulsants with 17 of 34 having at least one report, those most frequently linked being lamotrigine [n=106], carbamazepine [22], levetiracetam [14], phenytoin [14], valproate [9], clonazepam [8] and zonisamide [7]; no mention of accompanying liver injury or whether attribution was as a single agent or one of several).
Han XD, Koh MJ, Wong SMY. (2019). Drug reaction with eosinophilia and systemic symptoms in a cohort of Asian children. Pediatr Dermatol. (Among 10 children with DRESS syndrome seen at a single, Singapore referral center between 2006 and 2016, 3 cases were attributed to sulfamethoxazole/trimethoprim, 2 to carbamazepine, 1 sulfasalazine, 2 phenobarbital and 1 to levetiracetam [latency 28 days] but none to phenytoin; all had ALT elevations [88 to 1172 U/L], bilirubin was elevated in 7, but none had acute liver failure and none were fatal).
Cano-Paniagua A, Amariles P, Angulo N, Restrepo-Garay M. (2019). Epidemiology of drug-induced liver injury in a University Hospital from Colombia: Updated RUCAM being used for prospective causality assessment. Ann Hepatol. (Among 286 patients with liver test abnormalities seen in a single hospital in Colombia over a 1 year period, 17 were diagnosed with drug induced liver injury, the most common cause being antituberculosis therapy [n=6] followed by anticonvulsants [n=3, 1 each due to phenytoin, gabapentin and valproate]).
Wang YH, Chen CB, Tassaneeyakul W, Saito Y, Aihara M, Choon SE, Lee HY, et al., Asian Severe Cutaneous Adverse Reaction Consortium. (2019). The medication risk of Stevens-Johnson Syndrome and toxic epidermal necrolysis in Asians: the major drug causality and comparison with the US FDA label. Clin Pharmacol Ther. (Among 1028 cases of SJS/TEN reported to registries in 8 Asian countries, the most frequently implicated class of drugs was anticonvulsants including carbamazepine [26%], phenytoin [13%], lamotrigine [10%], phenobarbital [2%] and oxcarbazepine [1.7%]; non-anticonvulsant causes included allopurinol [20%] and sulfamethoxazole [8%]).
Kim HK, Kim DY, Bae EK, Kim DW. (2020). Adverse skin reactions with antiepileptic drugs using Korea adverse event reporting system database, 2008-2017. J Korean Med Sci. (Among 2942 reports of cutaneous drug reactions made to a Korean pharmacovigilance registry between 2008 and 2017, 241 [8%] were for severe cutaneous reactions [DRESS in 109, SJS in 106 and TEN in 25], the most common causes of which were carbamazepine [24%], lamotrigine [24%], valproate [8%], phenytoin [6%] and oxcarbazepine [5%]; no mention of accompanying ALT elevations or hepatotoxicity ).
Low EXS, Zheng Q, Chan E, Lim SG. (2020). Drug induced liver injury: East versus West - a systematic review and meta-analysis. Clin Mol Hepatol. (Systematic review of surveys of drug induced liver injury comparing 16 studies from Western countries with 26,069 cases and 12 studies from Eastern countries with 33,294 cases; phenytoin was the second most common cause of liver injury in studies from the East [25 cases: 3.5%]).
Sridharan K, Daylami AA, Ajjawi R, Ajooz HAMA. (2020). Drug-induced liver injury in critically ill children taking antiepileptic drugs: a retrospective study. Curr Ther Res Clin Exp. (Among 41 children admitted to a pediatric intensive care unit who received anticonvulsants for seizure control, 5 of 9 receiving phenobarbital alone, 9 of 12 receiving phenytoin alone but none of six receiving valproate developed liver test abnormalities (all hepatocellular), the timing, height and outcome of which were not given).
Vignesh V, Rameshkumar R, Mahadevan S. (2020). Comparison of phenytoin, valproate and levetiracetam in pediatric convulsive status epilepticus: a randomized double-blind controlled clinical trial. Indian Pediatr. (Among 110 children with status epilepticus not responding to intravenous benzodiazepine who were treated with intravenous infusions of phenytoin, valproate or levetiracetam, the rate of seizure control was similar in the 3 groups and adverse events were rare; no mention of liver injury or ALT elevations).

## OTHER REFERENCE LINKS

1 Recent References on Phenytoin: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(phenytoin/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%222009/11/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Phenytoin: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Phenytoin)